# Etanercept

## OVERVIEW

### Introduction

Etanercept is an antagonist of tumor necrosis factor alpha (TNFα) which has potent antiinflammatory activity and is used widely in severe forms of rheumatoid arthritis and psoriasis. Etanercept has been linked to rare instances of acute, clinically apparent liver injury.

### Background

Etanercept (ee tan' er sept) is a soluble form of the human TNFα receptor which is fused with the Fc portion of immunoglobulin G. This recombinant receptor binds soluble TNFα and the fused immunoglobulin protein facilitates its update and degradation. The decrease in serum TNFα leads to inhibition of pathways of inflammation and pain mediated by this potent, pro-inflammatory cytokine. Etanercept was approved for use in the United States in 1998, and current indications include moderate to severe rheumatoid arthritis, juvenile idiopathic (rheumatoid) arthritis, ankylosing spondylitis, psoriatic arthritis and severe psoriasis. Unlike infliximab, adalimumab, golimumab, and certolizumab, etanercept has not been shown to be effective in inflammatory bowel disease, possibly because it targets soluble and not tissue-bound TNF. Etanercept is considered a disease modifying antirheumatic drug (DMARD) and has been shown to improve symptoms as well as joint and cartilage damage in the inflammatory arthritidies. Etanercept is available in 25 mg and 50 mg/mL prefilled syringes, autoinjectors, and single use vials under the brand name of Enbrel. The typical maintenance dose in adults with rheumatoid arthritis is 50 mg subcutaneously once weekly. Common side effects include injection site reactions, gastrointestinal upset, rhinitis, rash and fever. Potential serious adverse events of TNFα antagonists include significant immune suppression, bone marrow suppression, severe infections, neurologic reactions, heart failure, hepatotoxicity, reactivation of tuberculosis and hepatitis B, and increased risk for malignancies including lymphomas.

### Hepatotoxicity

Etanercept has been associated with low rates of serum ALT elevations during therapy that are generally asymptomatic, transient, and do not require dose modifications. There have been isolated reports of clinically apparent liver injury during etanercept therapy, but the frequency has been far less than with infliximab, and most cases are mild and anicteric. Etanercept therapy can be associated with induction of autoantibodies, including antinuclear antibody (ANA) and cases of autoimmune hepatitis, induced or exacerbated by etanercept therapy have been reported. The latency to onset has ranged greatly, from as short as 2 weeks to as long as several years. The pattern of serum enzyme elevations has also varied, both cholestatic and hepatocellular injury being reported, the hepatocellular pattern being most frequent. Immunoallergic manifestations such as fever, rash and eosinophilia are rare. Autoantibodies are not infrequent (and may be due to the underlying rheumatologic condition) and the injury is usually responsive to corticosteroid therapy. How frequently the disease recurs after corticosteroids are discontinued has not been carefully assessed. Importantly, patients with etanercept induced liver injury are often able to tolerate infliximab or other monoclonal anti-TNF agents without recurrence of liver injury. The reverse is also true - that patients with infliximab or adalimumab-related liver injury, once it resolves spontaneously or with corticosteroids, often tolerate therapy with etanercept.

Etanercept has been linked to rare cases of reactivation of hepatitis B, although less frequently than infliximab. Reactivation occurs in patients who are inactive HBsAg carriers, with normal serum aminotransferase levels and no or only low levels of HBV DNA in serum. The immune suppression caused by the immunomodulatory agent leads to an increase in HBV replication and rise in serum HBV DNA levels. With stopping immune suppression (or between cycles of therapy), restoration of immune function leads to an acute immunological response to the heightened viral replication and a flare of hepatitis, that can be severe and can result in hepatic failure and death. Reactivation in patients with anti-HBc without HBsAg (serologic pattern of previous HBV infection) has not been reported in patients treated with etanercept, but has been reported after therapy with other TNFα antagonists and more commonly with rituximab and after bone marrow transplantation. The anti-TNF inhibitors have little or no effect on hepatitis C virus levels and have been used safely in patients with chronic hepatitis C.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury caused by etanercept is likely due to induction of autoimmunity. While a high proportion of patients develop autoantibodies either de novo or in rising titer, only rarely do persons develop clinically apparent autoimmune conditions, such as a lupus-like syndrome or autoimmune hepatitis.

### Outcome and Management

The hepatotoxicity of etanercept has largely been mild and self-limiting, although sometimes requiring corticosteroid therapy. No instances of chronic hepatitis or vanishing bile duct syndrome have been reported. Patients who develop mild serum aminotransferase elevations without symptoms or jaundice may recover despite continuing therapy or with temporary discontinuation or modification of the dose. But careful monitoring should be maintained to ensure recovery and lack of relapse. Patients who develop an autoimmune hepatitis-like syndrome during etanercept therapy may not recover promptly with stopping the drug and may require corticosteroid therapy which often is followed by improvement in liver tests. In this event, the dose of the corticosteroid should be kept to a minimum to control the disease and, ultimately, attempts made to withdraw immune suppression (or decrease to levels used before administration of etanercept). Most but not all patients with hepatotoxicity due to etanercept can be safely treated with a monoclonal antibody based TNFα antagonist (such as infliximab, adalimumab, certolizumab, or golimumab); if such therapy is planned, it should be done with caution and with laboratory monitoring for liver injury.

Patients who are to start etanercept therapy should be screened for evidence of hepatitis B, and those with preexisting HBsAg should be offered prophylaxis with a potent, oral antiviral agent such as tenofovir or entecavir.

Drug Class: Antirheumatic Agents; Dermatologic Agents

Other Drugs in the Subclass, Tumor Necrosis Factor Antagonists: Adalimumab, Certolizumab [underlined: pegol], Golimumab, Infliximab

## CASE REPORT

### Case 1. Autoimmune hepatitis arising during etanercept therapy.(1)

A 9 year old girl with juvenile idiopathic (rheumatoid) arthritis was treated with etanercept and hydroxychloroquine after she had failed to respond to a regimen of methotrexate, low dose prednisone and nonsteroidal antiinflammatory agents. Her dose of etanercept was increased to 50 mg weekly, which was followed by clinical improvement and allowed for lowering of the prednisone dose. Ten months after starting etanercept, she developed fatigue, abdominal discomfort and jaundice. Examination showed jaundice without fever, rash or signs of chronic liver disease. Laboratory results showed elevations in serum bilirubin (12 mg/dL) and aminotransferase levels (ALT 354 U/L, AST 486 U/L) with normal alkaline phosphatase levels. Tests for hepatitis A, B and C and Epstein-Barr virus were negative. Serum ANA was positive at 1:640 and SMA at 1:80, while antibodies to dsDNA and liver-kidney microsomal antigen were negative. Serum IgG levels were markedly increased (3637 mg/dL: normal <1600 mg/dL). Abdominal ultrasound was normal except for mild splenomegaly. A liver biopsy was consistent with autoimmune hepatitis with interface hepatitis and lobular necrosis with inflammation. Etanercept and hydroxychloroquine were discontinued, the dose of prednisone was increased to 2 mg/kg/day, and azathioprine was added. Her jaundice resolved, serum aminotransferase levels fell into the normal range, and autoantibodies became negative within 8 months of stopping etanercept.

#### Key Points

Medication: | Etanercept (50 mg once weekly)
Pattern: | Hepatocellular
Severity: | 3+ (jaundice, hospitalization)
Latency: | 10 months
Recovery: | Within 8 months (on prednisone)
Other medications: | Hydroxychloroquine, prednisone (5 mg daily), naproxen

#### Comment

A child with juvenile idiopathic arthritis (formerly known as juvenile rheumatoid arthritis) developed clinically apparent autoimmune hepatitis after 10 months of etanercept therapy. While it seems clear that the clinical syndrome was due to an autoimmune-like hepatitis, it is not certain whether the hepatitis was caused by etanercept directly or was a preexisting diathesis that was triggered or merely worsened by the immunomodulatory therapy and reduction in dose of prednisone. The child improved upon stopping etanercept, but the improvement may have been due to the concurrent increase in prednisone dose and addition of azathioprine. Information on long term follow up and whether azathioprine or prednisone could be discontinued (or lowered to previous low levels) might help to resolve these issues. However, many cases of autoimmune hepatitis associated with anti-TNF therapies (and other biologic agents such as the interferons) have appeared to be a triggering of autoimmune hepatitis in a susceptible patient, rather than the de novo induction of an autoimmune hepatitis-like liver injury that then resolves entirely with stopping therapy (as is typical of nitrofurantoin, minocycline, or methyldopa). These different interpretations have important implications for the long term management of such patients; i.e. whether long term immune suppression will be required.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Etanercept – Enbrel®

DRUG CLASS

Antirheumatic Agents; Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Etanercept)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Etanercept | 185243-69-0 | Monoclonal antibody | Not available

## CITED REFERENCES

1 Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol 2008; 14: 297-8. 18824922

## ANNOTATED BIBLIOGRAPHY

References updated: 21 February 2026

Abbreviations Used: TNF, tumor necrosis factor alpha; anti-TNF, antibody to TNF; ANA, anti-nuclear antigen; dsDNA, double stranded DNA; HBV, hepatitis B virus; HBsAg, hepatitis B surface antigen; anti-HBs, antibody to HBsAg; anti-HBc, antibody to hepatitis B core antigen; HBeAg, hepatitis B e antigen; anti-HBe, antibody to HBeAg; HCV, hepatitis C virus, anti-HCV, antibody to HCV.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; no mention of etanercept or other anti-tumor necrosis factor (anti-TNF) agents).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents published in 2013; all of the monoclonal anti-TNF agents have been linked to cases of hepatoxicity ranging in severity from asymptomatic aminotransferase elevations to acute liver failure).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Peterson JR, Hsu FC, Simkin PA, Wener MH. Effect of tumour necrosis factor alpha antagonists on serum transaminases and viraemia in patients with rheumatoid arthritis and chronic hepatitis C infection. Ann Rheum Dis 2003; 62: 1078-82. (Monitoring of 24 patients with both rheumatoid arthritis and hepatitis C found no overall changes in ALT, AST, Alk P or HCV RNA levels during therapy with etanercept or infliximab over a period of 2-34 months). 14583571
Khanna D, McMahon M, Furst DE. Safety of tumour necrosis factor-alpha antagonists. Drug Saf 2004; 27: 307-24. (Review of safety of anti-TNF agents based on literature and FDA reports found no evidence of worsening of hepatitis C during therapy, but chance of reactivation of hepatitis B, at least by infliximab; no discussion of hepatotoxicity). 15061685
Parke FA, Reveille JD. Anti-tumor necrosis factor agents for rheumatoid arthritis in the setting of chronic hepatitis C infection. Arthritis Rheum 2004; 51: 800-4. (Among 5 patients with rheumatoid arthritis and HCV infection who were treated with etanercept or infliximab for 8 to 49 months, none had worsening of serum ALT levels and HCV RNA levels were stable or decreased). 15478165
Magliocco MA, Gottlieb AB. Etanercept therapy for patients with psoriatic arthritis and concurrent hepatitis C virus infection: report of 3 cases. J Am Acad Dermatol 2004; 51: 580-4. (Three men, ages 51-54 years, with psoriasis and chronic hepatitis C received etanercept for 3-7 months with no change in serum ALT or AST levels and slight decrease in HCV RNA levels in two). 15389194
Calabrese LH, Zein N, Vassilopoulos D. Safety of antitumour necrosis factor (anti-TNF) therapy in patients with chronic viral infections: hepatitis C, hepatitis B, and HIV infection. Ann Rheum Dis 2004; 63 Suppl 2: ii18-ii24. (Review of the safety and complications of anti-TNF therapy in patients with concurrent hepatitis B or C or HIV infection). 15479865
Zein NN; Etanercept Study Group. Etanercept as an adjuvant to interferon and ribavirin in treatment-naive patients with chronic hepatitis C virus infection: a phase 2 randomized, double-blind, placebo-controlled study. J Hepatol 2005; 42: 315-22. (Controlled trial of adding etanercept to interferon and ribavirin therapy of chronic hepatitis C found similar rates of sustained response [32% vs 42%] and no evidence of worsening of hepatitis during etanercept therapy). 15791697
Desai SB, Furst DE. Problems encountered during anti-tumour necrosis factor therapy. Best Pract Res Clin Rheumatol 2006; 20: 757-90. (Extensive review of side effects of use of anti-TNF blockers; in 7 reports on 29 patients with hepatitis C, no flares of disease occurred on infliximab or etanercept; 11 report cases of use in hepatitis B with at least 3 instances of reactivation, one fatal, largely with infliximab and methotrexate). 16979537
Roux CH, Brocq O, Breuil V, Albert C, Euller-Ziegler L. Safety of anti-TNF-alpha therapy in rheumatoid arthritis and spondyloarthropathies with concurrent B or C chronic hepatitis. Rheumatology(Oxford) 2006; 45: 1294-7. (Retrospective analysis of 6 patients with chronic hepatitis and inflammatory arthritis treated with anti-TNF agents for 3-39 months, none had risen in ALT or viral levels during therapy, but 3 with hepatitis B were also on lamivudine). 16603583
Sánchez Carazo JL, Mahiques Santos L, Oliver Martinez V. Safety of etanercept in psoriasis: a critical review. Drug Saf 2006; 29: 675-85. (Review of safety of etanercept focusing upon psoriasis; no discussion of hepatotoxicity). 16872241
Wahie S, Alexandroff A, Reynolds NJ. Hepatitis: a rare, but important, complication of infliximab therapy for psoriasis. Clin Exp Dermatol 2006; 31: 460-1. (64 year old man with psoriasis developed enzyme elevations [ALT 569 U/L, GGT 77 U/L, bilirubin normal] 1 week after a second infusion of infliximab, which resolved with 4 weeks and did not recur with etanercept therapy). 16681606
Nathan DM, Angus PW, Gibson PR. Hepatitis B and C virus infections and anti-tumor necrosis factor-. therapy: guidelines for clinical approach. J Gastro Hepatol 2006; 31: 1366-71. (Review and proposed guidelines for use of anti-TNF therapy in patients with underlying chronic viral hepatitis; recommended screening for HBV and HCV, careful monitoring during therapy and prophylaxis or early intervention with lamivudine in HBsAg-positive patients). 16911678
Rokhsar C, Rabhan N, Cohen SR. Etanercept monotherapy for a patient with psoriasis, psoriatic arthritis, and concomitant hepatitis C infection. J Am Acad Dermatol 2006; 54: 361-2. (53 year old man with severe psoriasis and hepatic fibrosis caused by methotrexate and hepatitis C responded well to etanercept while HCV RNA levels were unchanged). 16443079
Cecchi R, Bartoli L. Psoriasis and hepatitis C treated with anti-TNF alpha therapy (etanercept). Dermatol Online J 2006; 12: 4. (45 year old man with psoriasis and hepatitis C was treated with etanercept for 12 months and had no change in serum enzyme or HCV RNA levels). 17459290
De Simone C, Paradisi A, Capizzi R, Carbone A, Siciliano M, Amerio PL. Etanercept therapy in two patients with psoriasis and concomitant hepatitis C. J Am Acad Dermatol 2006; 54: 1102-4. (Letter in response to Magliocco [2004] reporting two patients with psoriasis and hepatitis C who tolerated 12 months of etanercept therapy with no change in serum tests and slight decrease in HCV RNA levels). 16713482
Calabrese LH, Zein NN, Vassilopoulos D. Hepatitis B virus (HBV) reactivation with immunosuppressive therapy in rheumatic diseases: assessment and preventive strategies. Ann Rheum Dis 2006; 65: 983-9. (Review of the problem of reactivation of hepatitis B in patients with rheumatic diseases treated with immunosuppressive agents with recommendations on prevention). 16627542
Koike R, Takeuchi T, Eguchi K, Miyasaka N; Japan College of Rheumatology. Update on the Japanese guidelines for the use of infliximab and etanercept in rheumatoid arthritis. Mod Rheumatol 2007; 17: 451-8. (Review of guidelines for the use of infliximab and etanercept in rheumatoid arthritis; no mention of hepatotoxicity or need to screen for hepatitis B). 18084695
Vassilopoulos D, Calabrese LH. Risks of immunosuppressive therapies including biologic agents in patients with rheumatic diseases and co-existing chronic viral infections. Curr Opin Rheumatol 2007; 19: 619-25. (Review of use of anti-TNF agents in patients with chronic hepatitis B, C and HIV infection). 17917544
Sakellariou GT, Chatzigiannis I. Long-term anti-TNF alpha therapy for ankylosing spondylitis in two patients with chronic HBV infection. Clin Rheumatol 2007; 26: 950-2. (Two patients with ankylosing spondylitis and inactive HBsAg carrier state who were treated with infliximab; 43 year old man developed reactivation after 14 weeks [ALT 49 U/L, HBV DNA positive] and was successfully treated with lamivudine; 41 year old man had ALT elevations [85 U/L], but no reactivation even when later switched to etanercept). 16865308
GarciíAparicio AM, Rey JR, Sanz AH, Alvarez JS. Successful treatment with etanercept in a patient with hepatotoxicity closely related to infliximab. Clin Rheumatol 2007; 26: 811-3. (48 year old man with ankylosing spondylitis developed mild ALT elevations [60 U/L] after second and higher levels [ALT 382 rising to 656 U/L, Alk P 166 U/L, bilirubin 0.6 mg/dL, ANA negative] after third and fourth infusion of infliximab, with no recurrence on switching to etanercept: infliximab Case 2). 16550301
Linardaki G, Katsarou O, Ioannidou P, Karafoulidou A, Boki K. Effective etanercept treatment for psoriatic arthritis complicating concomitant human immunodeficiency virus and hepatitis C virus infection. J Rheumatol 2007; 34: 1353-5. (45 year old man with HIV-HCV coinfection and psoriasis was successfully treated with etanercept without worsening of hepatitis while on antiretroviral therapy; ALT levels remained normal, but serial HCV RNA levels were not provided). 17552060
Marotte H, Fontanges E, Bailly F, Zoulim F, Trepo C, Miossec P. Etanercept treatment for three months is safe in patients with rheumatological manifestations associated with hepatitis C virus. Rheumatology (Oxford) 2007; 46: 97-9. (Among 9 patients with chronic hepatitis C and rheumatologic symptoms treated with etanercept for 3 months, serum ALT levels were stable and HCV RNA [present in 5] did not change). 16720634
Cansu DU, Kalifoglu T, Korkmaz C. Short-term course of chronic hepatitis B and C under treatment with etanercept associated with different disease modifying antirheumatic drugs without antiviral prophylaxis. J Rheumatol 2008; 35: 421-4. (Five patients with inflammatory arthritis, 3 with HCV, 1 with HBV and 1 with both, were treated with etanercept for 12-23 months; none had change in serum ALT or AST levels; viral levels fluctuated but without a specific pattern). 18203328
Thiéfen G, Morelet A, Heurgué, Diebold MD, Eschard JP. Infliximab-induced hepatitis: absence of cross-toxicity with etanercept. Joint Bone Spine 2008; 75: 737-9. (48 year old man with ankylosing spondylitis developed rising ALT levels [188 to 393 to 412 U/L] and ANA [1:200 to 1:1600] after 6 infusions of infliximab, which fell to normal 3 months after stopping, and patient was then treated with etanercept for 30 months without changes in ALT levels). 18693125
Dominique L. Liver toxicity of TNF alpha antagonists. Joint Bone Spine 2008; 75: 636-8. (Editorial in response to Thiéfin [2008]). 18952478
Farah M, Al Rashidi A, Owen DA, Yoshida EM, Reid GD. Granulomatous hepatitis associated with etanercept therapy. J Rheumatol 2008; 35: 349-51. (17 year old woman developed abnormal liver tests without symptoms 4 months after restarting etanercept [bilirubin normal, ALT 162 U/L, Alk P 267 U/L], a biopsy showing granulomas and bile duct injury, improved but did not resolve on stopping etanercept and using ursodiol). 18260163
Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol 2008; 14: 297-8. (9 year old girl with juvenile idiopathic [rheumatoid] arthritis developed abdominal pain and jaundice 10 months after starting etanercept [bilirubin 12.0 mg/dL, ALT 354 U/L, GGT 388 U/L, ANA 1:640, IgG 3637 mg/dL], stopping etanercept and starting prednisone and azathioprine led to resolution, normal liver tests and negative ANA: Case 1). 18824922
Ferri C, Ferraccioli G, Ferrari D, Galeazzi M, Lapadula G, Montecucco C, Triolo G, et al.; GISEA Group. Safety of anti-tumor necrosis factor-alpha therapy in patients with rheumatoid arthritis and chronic hepatitis C virus infection. J Rheumatol 2008; 35: 1944-9. (Prospective study in 31 patients with rheumatoid arthritis and hepatitis C treated with anti-TNF agents for 7-44 months [adalimumab 3, etanercept 17; infliximab 11]; mean levels of HCV RNA and ALT did not change; fluctuations occurred in a few patients, but no correlation found between changes in viral RNA and ALT levels). 18688917
Harada K, Akai Y, Koyama S, Ikenaka Y, Saito Y. A case of autoimmune hepatitis exacerbated by the administration of etanercept in the patient with rheumatoid arthritis. Clin Rheumatol 2008; 27: 1063-6. (50 year old woman with rheumatoid arthritis developed abdominal pain 2 weeks after a first injection of etanercept [bilirubin 1.2 mg/dL, ALT 300 U/L, Alk P 488 U/L, ANA 1:1280]; biopsy suggested autoimmune hepatitis and patient responded to prednisone therapy; may have had mild autoimmune hepatitis before starting therapy and also received diclofenac). 18563514
Becker H, Willeke P, Domschke W, Gaubitz M. Etanercept tolerance in a patient with previous infliximab-induced hepatitis. Clin Rheumatol 2008; 27: 1597-8. (Letter in response to Harada [2008]; 41 year old woman with seronegative rheumatoid arthritis developed elevated enzymes [ALT 1061 U/L, Alk P 244 U/L] after 3 years of infliximab therapy [ANA rising from 1:160 to 1:640], responding to stopping infliximab and prednisone therapy, later tolerating etanercept without ALT elevations and ANA levels falling to baseline). 18795397
Leak AM, Rincon-Aznar B. Hepatotoxicity associated with etanercept in psoriatic arthritis. J Rheumatol 2008; 35: 2286-7. (50 year old woman with psoriatic arthritis developed jaundice after 2 months of etanercept [50 mg/week] [bilirubin 2.4 mg/dL, ALT ~550 U/L, Alk P ~325 U/L], resolving within 3 months of stopping; but the patient later tolerated a lower dose of etanercept without recurrence of hepatitis, but with persistently borderline high Alk P levels). 19004062
Cansu DU, Kalifoglu T, Korkmaz C. Short-term course of chronic hepatitis B and C under treatment with etanercept associated with different disease modifying antirheumatic drugs without antiviral prophylaxis. J Rheumatol 2008; 35: 421-4. (Among 2 patients with HBsAg who received etanercept therapy for 12 and 13 months, serum HBV DNA levels rose minimally [from undetectable to 514 and 36 copies/mL] and ALT levels did not change; in 4 patients with hepatitis C treated with etanercept for 13-234 months, HCV RNA levels rose in 3, but ALT levels were only minimally elevated [<2 times ULN]). 18203328
Levämpi T, Korpela M, Vuolteenaho K, Moilanen E. Etanercept and adalimumab treatment in patients with rheumatoid arthritis and spondyloarthropathies in clinical practice: adverse events and other reasons leading to discontinuation of the treatment. Rheumatol Int 2008; 28: 261-9. (Among 17 patients who stopped anti-TNF therapy because of side effects, none were for hepatotoxicity). 17846778
Collazo MH, González JR, Torres EA. Etanercept therapy for psoriasis in a patient with concomitant hepatitis C and liver transplant. P R Health Sci J 2008; 27: 346-7. (49 year old man with psoriasis who underwent liver transplantation for liver cancer due to HCV and alcoholic cirrhosis was then treated with etanercept with excellent clinical results: AST levels were stable and HCV RNA levels decreased [from 822 to 1.3 million IU/mL). 19069362
Cavazzana I, Ceribelli A, Cattaneo R, Franceschini F. Treatment with etanercept in six patients with chronic hepatitis C infection and systemic autoimmune diseases. Autoimmun Rev 2008; 8: 104-6. (Among 6 patients with inflammatory arthritis and anti-HCV who were treated with etanercept, none had worsening of hepatitis and HCV RNA levels changed minimally [174,770 to 348,218 IU/mL]). 19014870
Domm S, Cinatl J, Mrowietz U. The impact of treatment with tumour necrosis factor-alpha antagonists on the course of chronic viral infections: a review of the literature. Br J Dermatol 2008; 159: 1217-28. (Review of literature on efficacy and safety of TNF antagonists in patients with chronic hepatitis B and C, recommends screening and monitoring). 18945310
Cassano N, Vena GA. Etanercept treatment in a hemodialysis patient with severe cyclosporine-resistant psoriasis and hepatitis C virus infection. Int J Dermatol 2008; 47: 980-1. (69 year old man on hemodialysis with severe psoriasis and chronic hepatitis C was treated successfully with etanercept without worsening or change in hepatitis C markers or ALT levels). 18937672
Boetticher NC, Peine CJ, Kwo P, Abrams GA, Patel T, Aqel B, Boardman L, et al. A randomized, double-blinded, placebo-controlled multicenter trial of etanercept in the treatment of alcoholic hepatitis. Gastroenterology 2008; 135: 1953-60. (Controlled trial in 48 patients with moderate-to-severe acute alcoholic hepatitis found a higher 6 month mortality rate with etanercept [58%] than placebo therapy [23%]). 18848937
Carroll MB, Bond MI. Use of tumor necrosis factor-alpha inhibitors in patients with chronic hepatitis B infection. Semin Arthritis Rheum 2008; 38: 208-17. (73 year old woman with rheumatoid arthritis and chronic hepatitis B with high levels of HBV DNA in serum was treated with etanercept and given lamivudine and later adefovir without sustained effects, and later followed on no antiviral therapy with no change in liver histology over a 5 year period). 18221983
Zingarelli S, Airò Frassi M, Bazzani C, Scarsi M, Puoti M. Prophylaxis and therapy of HBV infection in 20 patients treated with disease modifying antirheumatic drugs or with biological agents for rheumatic diseases. Reumatismo 2008; 60: 22-7. (Retrospective analysis of results of treating 20 HBsAg positive patients with rheumatic conditions using immunosuppressive biologic agents; all patients tolerated therapy well and none had reactivation while on prophylactic antiviral therapy). 18432322
Montiel PM, Solis JA, Chirinos JA, a Casis B, Sáchhez F, Rodríguez S. Hepatitis B virus reactivation during therapy with etanercept in an HBsAg-negative and anti-HBs-positive patient. Liver Int 2008; 28: 718-20. (73 year old man with ankylosing spondylitis, amyloidosis and anti-HBc without HBsAg in serum was treated with etanercept and prednisone and developed symptomatic hepatitis 14 months later [bilirubin 2.0 mg/dL, ALT 65 U/L, GGT 121 U/L], with appearance of HBsAg and HBV DNA [1507 U/mL], resolving on lamivudine and later restarting etanercept while continuing lamivudine without reactivation). 18433400
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 were attributed to etanercept, but none to infliximab, adalimumab or certolizumab). 18955056
Zingarelli S, Frassi M, Bazzani C, Scarsi M, Puoti M, Airò P. Use of tumor necrosis factor-alpha-blocking agents in hepatitis B virus-positive patients: reports of 3 cases and review of the literature. J Rheumatol 2009; 36: 1188-94. (3 patients with rheumatoid arthritis and HBsAg in serum treated with etanercept, infliximab or adalimumab for up to 3 years; 2 with lamivudine prophylaxis did not develop reactivation, 1 without prophylaxis developed mild reactivation at 6 months and was successfully treated with lamivudine; review of literature found reactivation to occur in 12 of 16 patients not given prophylaxis, but only mild rise in HBV DNA in 1 of 7 on lamivudine). 19447932
Robinson H, Walker-Bone K. Anti-TNF-alpha therapy for rheumatoid arthritis among patients with chronic hepatitis B infection. Rheumatology (Oxford) 2009; 48: 448-50. (63 year old woman with rheumatoid arthritis and inactive hepatitis B treated with various combinations of etanercept, adalimumab, prednisone and methotrexate had no evidence of significant reactivation after 2 years of therapy; on review of literature, authors conclude that prophylaxis is not usually necessary). 19223285
Caramaschi P, Bambara LM, Pieropan S, Tinazzi I, Volpe A, Biasi D. Anti-TNFalpha blockers, autoantibodies and autoimmune diseases. Joint Bone Spine 2009; 76: 333-42. (Review of frequency of appearance of autoantibodies and autoimmune conditions during anti-TNF therapy). 19539516
Carlsen KM, Riis L, Madsen OR. Toxic hepatitis induced by infliximab in a patient with rheumatoid arthritis with no relapse after switching to etanercept. Clin Rheumatol 2009; 28: 1001-3. (38 year old woman with rheumatoid arthritis developed rising ALT levels after 7 infusions of infliximab [ALT 234 U/L, bilirubin normal, ANA negative], resolving with stopping and no recurrence on switching to etanercept). 19370307
Chung SJ, Kim JK, Park MC, Park YB, Lee SK. Reactivation of hepatitis B viral infection in inactive HBsAg carriers following anti-tumor necrosis factor-alpha therapy. J Rheumatol 2009; 36: 2416-20. (Among 103 patients with rheumatoid arthritis or psoriasis treated with anti-TNF agents for 15-52 weeks, 8 were HBsAg-positive, but only 1 suffered reactivation; after third infusion with rise in ALT at week 14 peaking at 1054 U/L, HBV DNA 3.1 million copies/mL, entecavir therapy resulted in prompt improvements). 19797507
Dufour C, Giacchino R, Ghezzi P, Tonelli R, Ferretti E, Pitto A, Pistoia V, et al. Etanercept as a salvage treatment for refractory aplastic anemia. Pediatr Blood Cancer 2009; 52: 522-5. (17 year old man with aplastic anemia and chronic hepatitis C developed mild, transient ALT elevations [peak 176 U/L] during etanercept therapy). 19061218
Fairhurst DA, Sheehan-Dare R. Autoimmune hepatitis associated with infliximab in a patient with palmoplantar pustular psoriasis. Clin Exp Dermatol 2009; 34: 421-2. (22 year old woman with psoriasis developed rising ALT levels after third infusion of infliximab, peaking at ALT 1663 U/L 55 days after last infusion with rising in ANA [1:40 to 1:640] and a liver biopsy suggestive of autoimmune hepatitis, resolving with prednisone therapy; short follow up and no mention of bilirubin levels). 19309375
Kluger N, Girard C, Guillot B, Bessis D. Efficiency and safety of etanercept after acute hepatitis induced by infliximab for psoriasis. Acta Derm Venereol 2009; 89: 332-4. (46 year old woman with psoriasis developed rise in ALT [369 U/L] after a fourth infusion of infliximab with negative ANA and bilirubin of 1.5 mg/dL, resolving within 6 weeks of stopping and no recurrence with etanercept). 19479148
Li S, Kaur PP, Chan V, Berney S. Use of tumor necrosis factor-alpha (TNF-alpha) antagonists infliximab, etanercept, and adalimumab in patients with concurrent rheumatoid arthritis and hepatitis B or hepatitis C: a retrospective record review of 11 patients. Clin Rheumatol 2009; 28: 787-91. (Retrospective analysis of 11 patients with rheumatoid arthritis and either hepatitis B [n=3] or C [n=8] during 3 to 60 months anti-TNF therapy, 3 had transient minimal ALT elevations [peak levels 51, 73 and 51 U/L], without symptoms or jaundice). 19291350
Massarotti M, Marasini B. Successful treatment with etanercept of a patient with psoriatic arthritis after adalimumab-related hepatotoxicity. Int J Immunopathol Pharmacol 2009; 22: 547-9. (46 year old man with psoriatic arthritis developed rising ALT levels [19 to 96 to 252 U/L] 2 months after starting adalimumab, with resolution within 2 months of stopping and no recurrence after switching to etanercept). 19505409
Wetter DA, Davis MD. Lupus-like syndrome attributable to anti-tumor necrosis factor alpha therapy in 14 patients during an 8-year period at Mayo Clinic. Mayo Clin Proc 2009; 84: 979-84. (Retrospective analysis of 14 cases of lupus-like syndrome arising during anti-TNF therapy [13 infliximab, 1 adalimumab] over 8 year period; all were ANA positive and most had anti-dsDNA, onset with rash, serositis, fatigue, arthralgias, oral ulcers, but no renal or CNS involvement, all improved on stopping and tolerated other but not the same anti-TNF agent; no hepatic manifestations mentioned). 19880688
Rodríguez Gil FJ, Martínez Crespo JJ, García Belmonte D, Nicolás de Prado I, de Prado Serrano R. [Jaundice in a patient treated with etanercept]. Gastroenterol Hepatol 2009; 32: 584-5. Spanish. PMID: 19523718 (62 year old woman with primary biliary cirrhosis on ursodiol with mild elevations in Alk P and bilirubin was started on etanercept for psoriasis and 2 months later developed deepening jaundice despite improvements in Alk P and ALT; bilirubin rose gradually to 12.7 mg/dL 5 months after stopping and subsequently fell to baseline as Alk P and ALT levels rose).
Charpin C, Guis S, Colson P, Borentain P, Mattéi JP, Alcaraz P, Balandraud N, et al. Safety of TNF-blocking agents in rheumatic patients with serology suggesting past hepatitis B state: results from a cohort of 21 patients. Arthritis Res Ther 2009; 11: R179. (21 patients with rheumatic conditions who had anti-HBc without HBsAg in serum and were monitored during 7-56 months of therapy with infliximab [4], etanercept [14] or adalimumab [2]; anti-HBs titers decreased minimally and no patient developed HBV DNA or HBsAg or features of reactivation). 19941642
Frankel AJ, Van Voorhees AS, Hsu S, Korman NJ, Lebwohl MG, Bebo BF Jr, Gottlieb AB; National Psoriasis Foundation. Treatment of psoriasis in patients with hepatitis C: from the Medical Board of the National Psoriasis Foundation. J Am Acad Dermatol 2009; 61: 1044-55. (Recommend that infliximab and etanercept be considered second line agents in patients with psoriasis and hepatitis C, and conclude that more studies are needed). 19811848
Prignano F, Zanieri F, Milani S, Lotti T. Switch from etanercept to efalizumab in a psoriatic patient with HCV infection: a case report. Dermatol Ther 2009; 22: 386-90. (40 year old man with severe psoriasis and chronic hepatitis C was treated with etanercept and then efalizumab for six months without worsening of hepatitis or significant change in HCV RNA levels). 19580583
Giannitti C, Benucci M, Caporali R, Manganelli S, Bellisai F, Sebastiani GD, Galeazzi M. Efficacy and safety of anti-TNF-alpha therapy combined with cyclosporine A in patients with rheumatoid arthritis and concomitant hepatitis C virus infection. Int J Immunopathol Pharmacol 2009; 22: 543-6. (7 patients with rheumatoid arthritis and chronic hepatitis C were treated with cyclosporine and either etanercept or adalimumab and had clinical improvements with no worsening of liver disease, but instead mild decreases in ALT [38 to 26 U/L] and HCV RNA levels [7.1 to 2.3 million IU/mL]). 19505408
Wendling D, Di Martino V, Prati C, Toussirot E, Herbein G. Spondyloarthropathy and chronic B hepatitis. Effect of anti-TNF therapy. Joint Bone Spine 2009; 76: 308-11. (Four patients with chronic hepatitis B and spondylitis treated with infliximab or etanercept; two who did not receive prophylaxis with lamivudine developed rising HBV DNA levels within a month of starting therapy, which then responded to lamivudine therapy). 19346146
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. Life threatening liver disease during treatment with monoclonal antibodies. BMJ 2009; 338: b508. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF] and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow but eventual recovery). 19224957
Shale MJ, Seow CH, Coffin CS, Kaplan GG, Panaccione R, Ghosh S. Review article: chronic viral infection in the anti-tumour necrosis factor therapy era in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 20-34. (Extensive review of literature on effects of anti-TNF therapies on underlying chronic hepatitis B and C; among 28 HBV-infected patients, reactivation was common in those not on antiviral therapy, more frequent with monoclonal antibodies than etanercept; among 110 HCV-infected patients, little evidence of worsening of disease and in some instances a decrease in HCV RNA levels). 19681818
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of the hepatotoxicity of drugs used to treat inflammatory bowel disease focusing upon sulfasalazine, thiopurines, TNF inhibitors, and methotrexate). 20926880
Haennig A, Bonnet D, Thebault S, Alric L. Infliximab-induced acute hepatitis during Crohn's disease therapy: absence of cross-toxicity with adalimumab. Gastroenterol Clin Biol 2010; 34: e7-8. (46 year old man with Crohn disease developed elevations in ALT [284 and 528 U/L] without Alk P and bilirubin elevations or symptoms after first 3 doses of infliximab, falling to normal in 3 months and not recurring during 6 months of adalimumab therapy). 20189334
Cravo M, Silva R, Serrano M. Autoimmune hepatitis induced by infliximab in a patient with Crohn's disease with no relapse after switching to adalimumab. BioDrugs 2010; 24 Suppl 1:25-7. (38 year old woman with Crohn disease was on and off infliximab for 8 years, developed abnormal liver tests [bilirubin normal, ALT 191 U/L, ANA 1:640], responding to prednisolone and azathioprine within 12 weeks and later treated with adalimumab without worsening of liver disease, but on long term azathioprine [50 mg/day]). 21175232
Katsanos KH, Tsianos VE, Zois CD, Zioga H, Vagias I, Zervou E, Christodoulou DK, et al.; Northwest Greece IBD Study Group. Inflammatory bowel disease and hepatitis B and C in Western Balkans: a referral centre study and review of the literature. J Crohns Colitis 2010; 4: 450-65. (Among 482 patients with inflammatory bowel disease, 11 had HBV and 4 HCV, antiviral therapy for which did not worsen the underlying bowel disease). 21122543
Which TNF inhibitor for rheumatoid arthritis? Med Lett Drugs Ther 2010; 52 (1338): 38-9. (Discussion of the efficacy, safety and costs of the 5 TNF inhibitors approved for use in rheumatoid arthritis states that none have been shown to be more effective than any other and adverse effects are similar, although reactivation of tuberculosis may be less common with etanercept than infliximab). 20467356
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of 37 publications on 153 patients with hepatitis C who were treated with anti-TNF agents for an average of 12 months found only one instance of worsening during therapy and no evidence of increases in HCV RNA levels during treatment). 21690185
Fotiadou C, Lazaridou E, Ioannides D. Safety of anti-tumour necrosis factor-agents in psoriasis patients who were chronic hepatitis B carriers: a retrospective report of seven patients and brief review of the literature. J Eur Acad Dermatol Venereol 2011; 25: 471-4. (Seven patients with psoriasis and HBsAg carrier state were treated with adalimumab, etanercept or infliximab for 6-24 months with lamivudine prophylaxis and none suffered reactivation, HBV DNA being undetectable or present at low levels). 20561122
Carroll MB, Forgione MA. Use of tumor necrosis factor alpha inhibitors in hepatitis B surface antigen-positive patients: a literature review and potential mechanisms of action. Clin Rheumatol 2010; 29: 1021-9. (Review of literature on anti-TNF therapy in patients with hepatitis B identified 35 cases, 7 cases of reactivation occurred, including 7 of 17 on infliximab but none of 12 on etanercept or 6 on adalimumab; 18 received lamivudine, but only 7 as prophylaxis). 20556450
Caporali R, Bobbio-Pallavicini F, Atzeni F, Sakellariou G, Caprioli M, Montecucco C, Sarzi-Puttini P. Safety of tumor necrosis factor alpha blockers in hepatitis B virus occult carriers(hepatitis B surface antigen negative/anti-hepatitis B core antigen positive) with rheumatic diseases. Arthritis Care Res (Hoboken) 2010; 62: 749-54. (Among 732 patients treated with anti-TNF agents, 5 had HBsAg and were given prophylaxis with lamivudine and 67 had anti-HBc without HBsAg [25 on infliximab, 23 etanercept, 19 adalimumab], none of whom developed HBsAg or reactivation during an average follow up of 3.5 years). 20535784
Gandhi RK, Pickup T, Sheth PB. Is etanercept safe for treating plaque psoriasis in a patient with chronic hepatitis C virus infection? Arch Dermatol 2010; 146: 1151-2. (58 year old man with severe psoriasis and hepatitis C was treated successfully with etanercept and was reported to become HCV RNA negative during treatment). 20956650
Garavaglia MC, Altomare G. Etanercept therapy in patients with psoriasis and concomitant HCV infection. Int J Immunopathol Pharmacol 2010; 23: 965-9. (5 patients with psoriasis and chronic hepatitis C were treated with etanercept for up to 2 years; HCV RNA and ALT levels changed minimally in 4 and rose in 1 who was then treated with peginterferon and ribavirin). 20943071
Prestinari F, Ferguglia G, Laria G. Etanercept in a patient with severe psoriasis and latent viral hepatic disease and latent tuberculosis. Am J Clin Dermatol 2010; 11 Suppl 1: 57-8. (63 year old man with psoriasis, tuberculin positivity and anti-HBc without HBsAg was treated with isoniazid and etanercept without reactivation or appearance of liver injury). 20586514
Bordas X, Martín Sala S. [Etanercept and chronic infection by HCV and HBV]. Actas Dermosifiliogr. 2010; 101 Suppl 1: 82-7. Spanish. PMID: 20492886 (Review of the safety of antirheumatic agents in patients with chronic viral hepatitis, and case report of 55 year old woman with psoriasis and chronic hepatitis B treated with lamivudine and etanercept with no worsening of liver disease and improvement in psoriasis).
Vassilopoulos D, Apostolopoulou A, Hadziyannis E, Papatheodoridis GV, Manolakopoulos S, Koskinas J, Manesis EK, et al. Long-term safety of anti-TNF treatment in patients with rheumatic diseases and chronic or resolved hepatitis B virus infection. Ann Rheum Dis 2010; 69: 1352-5. (Among 131 patients with rheumatic conditions treated with anti-TNF, 14 had HBsAg [all were given prophylactic anti-HBV therapy], 19 had anti-HBs alone [from vaccination], and 19 anti-HBc [from previous infection]; during an average of 2 years of therapy, one patient with HBsAg on lamivudine developed rising titers of HBV DNA successfully treated with tenofovir, while all others had no change in serologic status or ALT levels). 20472596
Paradisi A, Caldarola G, Capizzi R, Siciliano M, Annichiarico E, Vecchio FM, Amerio PL, et al. Safety of etanercept in patients with psoriasis and hepatitis C virus assessed by liver histopathology: preliminary data. J Am Acad Dermatol 2010; 62: 1067-9. (Two men, ages 43 and 62 years, with severe psoriasis and chronic hepatitis C were treated with etanercept; monitoring of serum ALT and HCV RNA levels and liver histology showed no change during 12 months of therapy). 20466184
Kim YJ, Bae SC, Sung YK, Kim TH, Jun JB, Yoo DH, Kim TY, et al. Possible reactivation of potential hepatitis B virus occult infection by tumor necrosis factor-alpha blocker in the treatment of rheumatic diseases. J Rheumatol 2010; 37: 346-50. (Among 266 Korean patients with rheumatic conditions receiving anti-TNF therapy, 8 had HBsAg and 88 anti-HBc without HBsAg; 2 of the 8 HBsAg-positive patients developed reactivation and ALT elevations were more common in the anti-HBc-positive group [16%] than the antibody-negative group [6%], but reactivation was not demonstrated and clinical features were not given). 20008922
Ventura F, Gomes J, Duarte Mda L, Fernandes JC, Brito C. Efficacy and safety of etanercept in patients with psoriasis and hepatitis C. Eur J Dermatol 2010; 20: 808-9. (Two patients; 35 year old man and 47 year old woman with psoriasis and chronic hepatitis C were treated with etanercept with no change in serum ALT [36 to 44 U/L and 40 to 36 U/L], while HCV RNA levels increased in one and decreased in the other). 20923749
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to TNF antagonists). 20949552
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, et al. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Among 24 patients with drug induced autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, implicated agents included minocycline [n=11], nitrofurantoin [n=11], cephalexin [n=1] and "Prometrium" [n=1], none being attributed to TNF antagonists). 20512992
Goldfeld DA, Verna EC, Lefkowitch J, Swaminath A. Infliximab-induced autoimmune hepatitis with successful switch to adalimumab in a patient with Crohn's disease: the index case. Dig Dis Sci 2011; 56: 3386-8. (58 year old woman with Crohn disease developed liver test abnormalities several weeks after starting infliximab [bilirubin normal, ALT ~205 U/L, ANA 1:2560], which resolved on stopping and did not recur on starting adalimumab). 21597977
Koike T, Harigai M, Inokuma S, Ishiguro N, Ryu J, Takeuchi T, Tanaka Y, et al. Postmarketing surveillance of safety and effectiveness of etanercept in Japanese patients with rheumatoid arthritis. Mod Rheumatol 2011; 21: 343-51. (Summary of 6 month postmarketing surveillance of 13,894 Japanese patients with rheumatoid arthritis treated with etanercept; adverse events were reported in 31% and were severe in 6.2%, severe reactions including pneumonia and interstitial lung disease; abnormal liver tests were reported in 328 patients [2.4%], which were severe in 15 [0.1%]). 21264488
Stine JG, Bass M, Ibrahim D, Khokhar OS, Lewis JH. Dermatologists' awareness of and screening practices for hepatitis B virus infection before initiating tumor necrosis factor-α inhibitor therapy. South Med J 2011; 104: 781-8. (Results of email questionnaire sent to 1,000 US dermatologists found that 52% of 62 respondents were aware of guidelines for screening for HBV before using anti-TNF agents, but only 42% routinely screened patients and none of the 62 had ever seen a case of HBV reactivation). 22089354
Pérez-Alvarez R, Díaz-Lagares C, García-Hernández F, Lopez-Roses L, Brito-Zerón P, Pérez-de-Lis M, Retamozo S, et al.; BIOGEAS Study Group. Hepatitis B virus (HBV) reactivation in patients receiving tumor necrosis factor (TNF)-targeted therapy: analysis of 257 cases. Medicine (Baltimore) 2011; 90: 359-71. (Systematic review of literature identified 257 patients with preexisting HBV markers who received anti-TNF therapy, reactivation occurred in 39% of 89 patients with HBsAg [5 had acute liver failure, 4 died], but only 5% of 168 with anti-HBc without HBsAg [1 died]; lamivudine prophylaxis decreased, but did not eliminate reactivation [62% vs 23% in HBsAg carriers). 22033451
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of literature identified 153 patients with chronic hepatitis C treated with anti-TNF agents, mostly etanercept, with only 1 with definite worsening of disease on treatment). 21690185
Manzano-Alonso ML, Castellano-Tortajada G. Reactivation of hepatitis B virus infection after cytotoxic chemotherapy or immunosuppressive therapy. World J Gastroenterol 2011; 17: 1531-7. (Review of reactivation of hepatitis B with chemotherapy or immune suppression discusses 11 cases attributed to infliximab and 7 to etanercept). 21472116
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of liver injury due to antirheumatic drugs discusses ALT elevations caused by anti-TNF agents and autoimmune hepatitis due to infliximab). 21263458
Zanni M, Missale G, Santilli D, Di Nuzzo S. Etanercept in the treatment of psoriasis and psoriatic arthritis with concomitant hepatitis C virus infection: clinical and virological study in three patients. Eur J Dermatol 2011; 21: 564-7. (Three patients with psoriasis and hepatitis C were treated with etanercept and had good clinical responses without changes in HCV RNA levels, and only one patient [who also had alcoholic liver disease] showed any worsening of serum enzyme levels). 21543290
Iwamoto M, Minota S. Successful treatment with very low-dose etanercept in a patient with etanercept-induced liver dysfunction. Rheumatol Int 2011; 31: 561-2. (37 year old woman with rheumatoid arthritis developed ALT elevations [peak value 165 U/L] 12 weeks after starting etanercept, 25 mg weekly, which improved on stopping but remained normal on a dose of 12.5 mg every other week). 20349067
van Denderen JC, Blom GJ, van der Horst-Bruinsma IE, Dijkmans BA, Nurmohamed MT. Elevated liver enzymes in patients with ankylosing spondylitis treated with etanercept. Clin Rheumatol 2012; 31: 1677-82. (Among 105 patients with ankylosing spondylitis treated with etanercept, 9 developed liver enzyme elevations considered to be due to treatment leading to discontinuation in 2). 22941219
Kuroda T, Wada Y, Kobayashi D, Sato H, Murakami S, Nakano M, Narita I. Effect of etanercept and entecavir in a patient with rheumatoid arthritis who is a hepatitis B carrier: a review of the literature. Rheumatol Int 2012 32: 1059-63. (48 year old woman with rheumatoid arthritis and inactive hepatitis B was treated with entecavir and etanercept, with good response and no evidence of reactivation of hepatitis B). 20062998
Jansen TL, Mulder CJ. Rheumatology meets hepatology in 2012: a clinician's guideline for TNF inhibitors in hepatitis B/C virus carriers. Expert Opin Biol Ther 2012; 12: 391-3. (Review of the problem of hepatitis B and C in patients undergoing anti-TNF therapy, with recommendations on screening and management). 22413822
Viganò M, Degasperi E, Aghemo A, Lampertico P, Colombo M. Anti-TNF drugs in patients with hepatitis B or C virus infection: safety and clinical management. Expert Opin Biol Ther 2012; 12: 193-207. (Review of the safety of anti-TNF agents in patients with hepatitis B or C and expert opinion guidelines for screening and management). 22188392
Cho YT, Chen CH, Chiu HY, Tsai TF. Use of anti-tumor necrosis factor-α therapy in hepatitis B virus carriers with psoriasis or psoriatic arthritis: a case series in Taiwan. J Dermatol 2012; 39: 269-73. (Retrospective analysis of 7 patients with psoriasis and HBsAg in serum who were treated with anti-TNF therapy and were monitored for changes in HBV DNA levels, found HBV reactivation in 3 patients who were then treated and none developed clinically apparent hepatitis). 22077677
Grasland A, Sterpu R, Boussoukaya S, Mahe I. Autoimmune hepatitis induced by adalimumab with successful switch to abatacept. Eur J Clin Pharmacol 2012; 68: 895-8. (35 year old woman with seronegative arthritis developed rise in ALT [from 18 to 266 U/L, ANA 1:80, SMA 1:320] two months after starting adalimumab, which fell to normal on stopping prednisone therapy and did not recur on starting abatacept). 22205272
Sandhu A, Alameel T, Dale CH, Levstik M, Chande N. The safety and efficacy of antitumour necrosis factor-alpha therapy for inflammatory bowel disease in patients post liver transplantation: a case series. Aliment Pharmacol Ther 2012; 36: 159-65. (Retrospective analysis of 6 patients who were treated with infliximab for inflammatory bowel disease after liver transplantation, 4 of whom had an excellent clinical response and none of whom developed liver injury or graft rejection). 22616981
Vassilopoulos D, Calabrese LH. Management of rheumatic disease with comorbid HBV or HCV infection. Nat Rev Rheumatol 2012; 8: 348-57. (Clinical review of chronic hepatitis B and C and the implications in patients with rheumatic disorders with interpretation of virologic markers and recommendations for screening and prophylaxis against HBV during immunosuppressive therapy) 22565315
Titos Arcos JC, Hallal H, Robles M, Andrade RJ. Recurrent hepatotoxicity associated with etanercept and adalimumab but not with infliximab in a patient with rheumatoid arthritis. Rev Esp Enferm Dig 2012; 104: 282-4. (47 year old woman with rheumatoid arthritis developed liver test abnormalities without symptoms 2 years after starting etanercept [bilirubin not given, ALT 13 times ULN, Alk P 1.7 times ULN], resolving within 3 months of stopping, but recurring on adalimumab but not on infliximab). 22662786
Abramson A, Menter A, Perrillo R. Psoriasis, hepatitis B, and the tumor necrosis factor-alpha inhibitory agents: a review and recommendations for management. J Am Acad Dermatol 2012; 67: 1349-61. (Review of reactivation of hepatitis b by anti-TNF factors, particularly infliximab, and recommendations on screening). 22727462
Di Minno MN, Iervolino S, Peluso R, Russolillo A, Lupoli R, Scarpa R, Di Minno G, et al.; CaRRDS Study Group. Hepatic steatosis and disease activity in subjects with psoriatic arthritis receiving tumor necrosis factor-α blockers. J Rheumatol 2012; 39: 1042-6. (Ultrasound assessment of liver fat was done before and after one year of anti-TNF therapy in 48 patients with psoriatic arthritis and 42 untreated controls; worsening of hepatic fat score occurred in 42% of patients, but only 14% of controls and, while worsening did not correlate with methotrexate therapy, it was more frequent in psoriatic patients with active arthritis). 22422493
Tanaka E, Urata Y. Risk of hepatitis B reactivation in patients treated with tumor necrosis factor-α inhibitors. Hepatol Res 2012; 42: 333-9. (Review of the problem of reactivation of hepatitis B after therapy with anti-TNF agents). 22150950
Aaltonen KJ, Virkki LM, Malmivaara A, Konttinen YT, Nordström DC, Blom M. Systematic review and meta-analysis of the efficacy and safety of existing TNF blocking agents in treatment of rheumatoid arthritis. PLoS One 2012; 7: e30275. (Systematic review of 26 controlled trials of anti-TNF agents for rheumatoid arthritis found similar rates of efficacy with different agents, but slightly lower rates of adverse events with etanercept, as assessed by rates of discontinuation for adverse events [risk ratio=0.71]). 22272322
Motaparthi K, Stanisic V, Van Voorhees AS, Lebwohl MG, Hsu S. From the Medical Board of the National Psoriasis Foundation: Recommendations for screening for hepatitis B infection prior to initiating anti-tumor necrosis factor-alfa inhibitors or other immunosuppressive agents in patients with psoriasis. J Am Acad Dermatol 2014;70:`78-86. PMID: 24220724 (Recommendations for screening and monitoring for hepatitis B in patients with psoriasis treated with anti-TNF agents).
Costa L, Caso F, Atteno M, Giannitti C, Spadaro A, Ramonda R, Vezzù M, Del Puente A, et al. Long-term safety of anti-TNF-α in PsA patients with concomitant HCV infection: a retrospective observational multicenter study on 15 patients. Clin Rheumatol 2014;33:273-6. 23975363 (Among 15 patients with psoriasis and chronic hepatitis C treated with TNF antagonists for 12 months or more at 4 Italian centers, serum ALT levels remained stable or decreased and no patient had evidence of exacerbation of the underlying liver disease).
Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al.; US Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepato 2013; 11: 558-64. (Description of 6 cases of acute liver injury due to TNF antagonists from the US included 5 women [83%], ages 28 to 54 years, onset after 2-52 weeks of treatment with infliximab [n=3], etanercept [n=2] or adalimumab [n=1], ANA present in 3, [peak bilirubin 1.5-34.2 mg/dL, ALT 384-1687 U/L, Alk P 83-1311 U/L], 5 treated with corticosteroids, but all ultimately recovered). 23333219
Lin MV, Blonski W, Buchner AM, Reddy KR, Lichtenstein GR. The influence of anti-TNF therapy on the course of chronic hepatitis C virus infection in patients with inflammatory bowel disease. Dig Dis Sci 2013; 58: 1149-56. (Among 4,274 patients with inflammatory bowel disease, 37 had concurrent hepatitis C of whom 5 were treated with infliximab, none of whom had an exacerbation of disease, and had stable or decreasing levels of ALT and HCV RNA in serum while on therapy). 23179145
Efe C. Drug induced autoimmune hepatitis and TNF-α blocking agents: is there a real relationship? Autoimmun Rev 2013; 1: 337-9. (Review of the literature and commentary on anti-TNF-induced autoimmune hepatitis indicating that liver injury from these agents is rare, but they can induce ANA reactivity and may trigger autoimmune hepatitis in susceptible patients). 22841985
Papa A, Felice C, Marzo M, Andrisani G, Armuzzi A, Covino M, Mocci G, et al. Prevalence and natural history of hepatitis B and C infections in a large population of IBD patients treated with anti-tumor necrosis factor-α agents. J Crohns Colitis 2013; 7: 113-9. (In a retrospective study of 301 Italian patients with inflammatory bowel disease, 1 had HBsAg [0.3%], 22 had anti-HBc [7%] and 4 had anti-HCV [1.3%], but only one with HCV RNA; but none developed reactivation or liver injury during anti-TNF therapy; the one patient with HBsAg received lamivudine prophylaxis). 22464811
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver iInjury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 4 of which were attributed to infliximab and one to etanercept). 23419359
Pompili M, Biolato M, Miele L, Grieco A. Tumor necrosis factor-α inhibitors and chronic hepatitis C: a comprehensive literature review. World J Gastroenterol 2013; 19: 7867-73. (Review of literature on effects of anti-TNF agents in patients with chronic hepatitis C [153 on etanercept, 40 infliximab and 23 adalimumab] for an average of 1 year found only 5 patients with ALT elevations above 3 times ULN, 9 with >1 log IU/mL increase in HCV RNA levels, and 3 withdrawn for this reason). 24307780
Nanau RM, Neuman MG. Safety of anti-tumor necrosis factor therapies in arthritis patients. J Pharm Pharm Sci 2014; 17: 324-61. (Extensive review of adverse events associated with anti-TNF agents including immune related events). 25224347
Li Z, Xiao S, Ren J, Zhang Y, Tu C, Ji F. Hepatotoxicity due to etanercept abated after dose reduction in a patient with pustular psoriasis and without compromised efficacy. Rev Esp Enferm Dig 2014; 106: 492-3. (26 year old man with psoriasis developed ALT elevations [305 U/L] 3 weeks after starting etanercept [50 mg weekly], yet levels remained normal after he recovered despite treatment with a lower dose [25 mg weekly]). 25490172
Feuerstein JD, Cheifetz AS. Miscellaneous adverse events with biologic agents (excludes infection and malignancy). Gastroenterol Clin North Am 2014; 43: 543-63. (Extensive review of side effects of anti-TNF agents mentions drug induced autoimmune hepatitis as a rare complication, for which reason episodic monitoring of liver tests is warranted). 25110258
Di Nuzzo S, Boccaletti V, Fantini C, Cortelazzi C, Missale G, Fabrizi G, Lotti T, et al. Are anti-TNF-α agents safe for treating psoriasis in hepatitis C virus patients with advanced liver disease? case reports and review of the literature. Dermatology 2015 Oct 8. [Epub ahead of print] (2 cases: 61 and 50 year old men with psoriatic arthritis and chronic hepatitis C and cirrhosis were treated successfully with etanercept, but developed hepatocellular cancer after 21 and 58 months of therapy). 26444967
Iannone F, La Montagna G, Bagnato G, Gremese E, Giardina A, Lapadula G. Safety of etanercept and methotrexate in patients with rheumatoid arthritis and hepatitis C virus infection: a multicenter randomized clinical trial. J Rheumatol 2014; 41: 286-92. (Among 29 patients with rheumatoid arthritis and chronic hepatitis C monitored carefully during 54 weeks of etanercept and methotrexate therapy, serum ALT, AST and HCV RNA levels did not change significantly and no patient stopped therapy because of worsening liver disease). 24429167
Rossi RE, Parisi I, Despott EJ, Burroughs AK, O'Beirne J, Conte D, Hamilton MI, Murray CD. Anti-tumour necrosis factor agent and liver injury: literature review, recommendations for management. World J Gastroenterol 2014; 20: 17352-9. (Review of the literature on liver injury during anti-TNF therapy stresses that most ALT elevations are mild-to-moderate and self-limiting even with continuation of therapy). 25516646
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; but none were attributed to a TNF antagonist). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to TNF antagonists: 1 to adalimumab, 2 etanercept, and 3 infliximab). 25754159
Bauer H, Luxembourger C, Gottenberg JE, Fournier S, Abravanel F, Cantagrel A, Chatelus E, et al.; Club Rhumatismes et Inflammation, a section of the French Society of Rheumatology. Outcome of hepatitis E virus infection in patients with inflammatory arthritidies treated with immunosuppressants: a French retrospective multicenter study. Medicine (Baltimore) 2015; 94: e675. (Survey of French physicians treating patients with rheumatic diseases identified 23 patients who developed acute hepatitis E while being treated with immunosuppressive regimens [10 on anti-TNF, 4 rituximab, 2 abatacept, 2 tocilizumab and 16 receiving methotrexate, 4 leflunomide and 1 cyclosporine]; all recovered and cleared HEV RNA, some after reduction in immunosuppression and 5 with ribavirin therapy). 25860212
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment, and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Capkin E, Karkucak M, Cosar AM, Ak E, Karaca A, Gokmen F, Budak BS, Tosun M. Treatment of ankylosing spondylitis with TNF inhibitors does not have adverse effect on results of liver function tests: a longitudinal study. Int J Rheum Dis 2015; 18: 548-52. (Among 94 patients with ankylosing spondylitis treated with infliximab [n=28], adalimumab [n=32] or etanercept [n=34], there was no change in mean ALT levels after 3 and 6 months of therapy). 24612551
Petríková J, Jarčuška P, Svajdler M, Pella D, Macejová Z. Autoimmune hepatitis triggered by adalimumab and allergic reactions after various anti-TNFα therapy agents in a patient with rheumatoid arthritis. Isr Med Assoc J 2015; 17: 256-8. (33 year old woman with rheumatoid arthritis developed fatigue after 3 doses of adalimumab [bilirubin not given, ALT 888 U/L, Alk P 348 U/L, ANA positive], biopsy showing interface hepatitis, resolving with prednisolone; later having allergic reactions to etanercept and certolizumab, but responding to anakinra). 26040057
Rodrigues S, Lopes S, Magro F, Cardoso H, Horta e Vale AM, Marques M, Mariz E, et al. Autoimmune hepatitis and anti-tumor necrosis factor alpha therapy: A single center report of 8 cases. World J Gastroenterol 2015; 21: 7584-8. (Among more than 600 patients treated with anti-TNF agents over a 7 year period, 8 developed autoimmune hepatitis [7 on infliximab, 1 adalimumab]; 3 men, 5 women, most with ANA, 2 symptomatic, no mention of jaundice; all responding to corticosteroids, 2 requiring long term therapy). 26140007
Björnsson ES, Gunnarsson BI, Gröndal G, Jonasson JG, Einarsdottir R, Ludviksson BR, Gudbjörnsson B, Olafsson S. Risk of drug-induced liver injury from tumor necrosis factor antagonists. Clin Gastroenterol Hepatol 2015; 13: 602-8. (Among 11 cases of liver injury from anti-TNF agents identified over a 5 year period in Iceland, 9 were due to infliximab [among 1076 patients treated=1:120], 1 adalimumab [270 treated] and 1 etanercept [430 treated]; 8 women, 3 men; latency 1 to 6 months; 5 were jaundiced [peak bilirubin 0.6-7.6 mg/dL, ALT 169-1658 U/L, Alk P 71-916 U/L], 8 hepatocellular, 2 cholestatic and 1 mixed injury; 8 had ANA, 5 were treated with corticosteroids [only 1 long term], 8 were switched to another anti-TNF agent without recurrence). 25131534
Parisi I, O'Beirne J, Rossi RE, Tsochatzis E, Manousou P, Theocharidou E, et al. Elevated liver enzymes in inflammatory bowel disease: the role and safety of infliximab. Eur J Gastroenterol Hepatol 2016; 28: 786-91. (In a retrospective analysis of liver test abnormalities in 305 patients with inflammatory bowel disease followed between 2008 and 2013, ALT elevations arose in 36% of patients, only slightly more commonly in those on infliximab [n=176: 39%] than on other agents [n=129: 33%], most elevations being mild and resolving spontaneously). 27015138
French JB, Bonacini M, Ghabril M, Foureau D, Bonkovsky HL. Hepatotoxicity associated with the use of anti-TNF-α agents. Drug Saf. 2016;39:199-208. (Short review of the clinical features and outcomes of liver injury attributed to TNF antagonists). 26692395
Chiu YM, Tang CH, Hung ST, Yang YW, Fang CH, Lin HY. A real-world risk analysis of biological treatment (adalimumab and etanercept) in a country with a high prevalence of tuberculosis and chronic liver disease: a nationwide population-based study. Scand J Rheumatol 2017:46:236-40. 27766916 (Nationwide population-based data on use of adalimumab [n=4049] and etanercept [n=5117] between 2007 and 2011, identified higher rates of serious hepatic events for adalimumab vs etanercept [0.75 vs 0.39 per 100 person years] as well as higher rates of tuberculosis [1.62 vs 0.57 per 100 person-years]).
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab [3 died], but none were attributed to etanercept, adalimumab or other TNF antagonists). 29564668
Lopetuso LR, Mocci G, Marzo M, D'Aversa F, Rapaccini GL, Guidi Let al. Harmful effects and potential benefits of anti-tumor necrosis factor (tnf)-α on the liver. Int J Mol Sci. 2018;19:2199. (Extensive review of both the hepatic benefits and harms of therapy with TNF antagonists, infliximab has been shown to cause an autoimmune-like liver injury as well as benefit it treated spontaneous autoimmune hepatitis, less is known about etanercept which appears to be less likely to cause hepatic injury than infliximab). 30060508
Peixoto A, Martins Rocha T, Santos-Antunes J, Aguiar F, Bernardes M, Vaz C, et al. Etanercept-induced granulomatous hepatitis as a rare cause of abnormal liver tests. Acta Gastroenterol Belg. 2019;82:93-95.. (76 year old man with rheumatoid arthritis on etanercept for 12 years developed weakness and liver test abnormalities [bilirubin normal, ALT 650 U/L, Alk P 132 U/L, GGT 552 U/L, ANA 1:320, AMA negative, INR normal] and liver biopsy showed portal inflammation and fibrosis and occasional granuloma and with stopping etanercept ALT, Alk P and GGT levels fell gradually over 2 months into the normal range). 30888761
Shah P, Larson B, Wishingrad M, Nissen N, Björnsson E, Sundaram V. Now you see it, now you do not: a case of infliximab-induced vanishing bile duct syndrome. ACG Case Rep J. 2019;6:e00134. (63 year old African American man with ulcerative colitis developed jaundice 3 months after starting infliximab [bilirubin 16.0 mg/dL, ALT 1,164 U/L, Alk P 464 U/L] with progressive jaundice despite stopping [peak bilirubin 55.3 mg/dL] and biopsy showing vanishing bile duct syndrome, and requiring liver transplantation 5 weeks after onset). 31620531
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
dGlintborg B, Georgiadis S, Loft AG, Linauskas A, Lindegaard H, Hendricks O, Jensen DV, et al. Hospital contacts due to hepatobiliary adverse events in >5000 patients with inflammatory joint disease treated with originator or biosimilar etanercept (SB4): an observational nationwide study applying linkage between DANBIO and national registries. Ann Rheum Dis. 2020;79:846-848. PMID: 32111583 (Analysis of Danish National Registries of patients during the 6 months after starting or switching to an etanercept biosimilar [SB4] for rheumatoid or psoriatic arthritis or ankylosing spondylitis found no evidence of a higher rate or severity of hepatobiliary adverse events with the biosimilar vs standard etanercept, the switch being mandated because of price).
Bruno CD, Fremd B, Church RJ, Daly AK, Aithal GP, Björnsson ES, Larrey D, et al. HLA associations with infliximab-induced liver injury. Pharmacogenomics J. 2020;20:681-686. (Amng 16 European patients with infliximab-induced liver injury compared to 60 matched controls, genome-wide association studies showed no apparent gene differences but imputation of HLA alleles found a higher carrier rate of B*39:01 in cases [n=4, carrier rate 25%] vs controls [none, estimated 2%). 32024945
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enzymes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, mostly with rheumatologic diseases, latency to onset median of 110 days, usually with moderate hepatocellular enzyme elevations and minimal increases in Alk P and bilirubin, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists; one case presented with a cholestatic enzymes that persisted and biopsy showed paucity of bile ducts). 34487751
Meunier L, Malezieux E, Bozon A, Meszaros M, Larrey D. Can azathioprine prevent infliximab-induced liver injury? J Hepatol. 2022;77:553-555. (Letter in response to Bjornsson [2021]: Among 320 patients with inflammatory bowel disease receiving infliximab, two [0.7%] developed hepatitis, both women, ages 40 and 52 years, on infliximab without azathioprine for 4 to 5 months, initial ALT 320 and 318 U/L, with autoimmune features and persistent enzyme elevations despite stopping, with favorable response to corticosteroids; the authors hypothesize that concurrent azathioprine therapy might prevent the immune-mediated hepatitis). 35218814
Núñez F P, Quera R, Bay C, Castro F, Mezzano G. Drug-induced liver injury used in the treatment of inflammatory bowel disease. J Crohns Colitis. 2022;16:1168-1176. (Review of the hepatic adverse events that occur with therapies of inflammatory bowel disease such as sulfasalazine, thiopurines, methotrexate, TNF antagonists, newer monoclonal and small molecule inhibitors, and sphingosine-1-phosphate modulators). 35044449
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; jaundice in 60% and fatal outcome in 4%; no mention of other TNF antagonists besides infliximab). 35899490
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Ayadi S, Merhaben S, Hadj Kacem L, Rammeh S, Mensi A, Belhadj Mabrouk E, Zaimi Y, Mouelhi L. Infliximab-induced autoimmune-like hepatitis in a patient with Crohn's disease: a case report. Future Sci OA. 2025;11:2482496. (64 year old woman with Crohn disease developed elevations in liver tests 15 months after adding infliximab to long-term azathioprine therapy [ALT 6.6 times ULN, Alk P 1.5 times ULN, bilirubin normal, ANA 1:1600, IgG elevated] responding to stopping both drugs and treatment with prednisone with normal liver tests 3 months later and having stopped corticosteroids). 40166860
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature on cases of severe liver injury attributed to TNF antagonists identified 12 reports of severe acute liver injury due to infliximab but only one due to adalimumab [Hagel 2011] and none due to golimumab, certolizumab pegol, or etanercept). 41086316
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: Still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of the clinical features, causes, diagnosis, and management of drug-induced autoimmune-like hepatitis mentions that etanercept has been reported to be a cause but much less frequently than infliximab). 41368109
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 1 was attributed to infliximab and none to etanercept or other TNF antagonists). 38992407
Kuo MH, Tseng CW, Tseng KC, Lu MC, Tung CH, Chen NT, Huang KY, et al. The relationship between TNF-α inhibitor potency and HBV reactivation in patients with rheumatic disorders. Liver Int. 2025;45:e70152.. (Among 72 HBsAg positive patients treated with anti-TNF without prophylaxis, 21 [29%] developed reactivation vs 2 of 39 [5%] with prophylaxis, and 28 of 600 [5%] with anti-HBc without HBsAg and without prophylaxis, reactivation being more frequent with adalimumab than with etanercept or golimumab). 40418092
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab). 41601665

## OTHER REFERENCE LINKS

1. Recent References on Etanercept: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Etanercept/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Etanercept: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Etanercept)